# Nimesulide

## OVERVIEW

### Introduction

Nimesulide is a nonsteroidal antiinflammatory drug (NSAID) with relative specificity for COX-2 that is not available in the United States, but is used widely in other countries in the treatment of acute pain. Nimesulide has been linked to a low rate of transient serum enzyme elevations during therapy, but also to many instances of clinically apparent acute liver injury that can be severe and can result in acute liver failure, need for emergency liver transplantation and death.

### Background

Nimesulide (ni mes' sul ide) is a unique NSAID that has a basic sulfonanilide structure. Like other NSAIDs, nimesulide inhibits the enzyme cyclo-oxygenase (COX), thereby blocking the formation of proinflammatory prostaglandins that are important in pain and inflammatory pathways. Unlike most conventional NSAIDs, however, nimesulide has a relative specificity for COX-2 activity, the form that is most closely related to pain pathways as opposed to COX-1, which has major effects of gastric mucosa cell protection and platelet function. Nimesulide has analgesic as well as antipyretic and antiinflammatory activities mediated by COX-2 actions, but has relatively scant effect on platelet function or loss of gastric cytoprotection which is associated with COX-1 activity. Nimesulide has a rapid onset of action and has other activities besides its effects of cyclo-oxygenases that may be important in its antiinflammatory and analgesic actions. Nimesulide was never marketed in the United States, but has been widely used in many countries of the world since its introduction in the 1990s. Current indications vary by country, but are generally limited to mild-to-moderate acute pain for which the recommended dose in adults is 100 mg twice daily for no more than 15 days. Chronic therapy is not generally recommended, and nimesulide is considered contraindicated in children. Nimesulide is available by prescription in the form of capsules or granules for oral suspension of 100 mg and as suppositories of 200 mg in both generic and trade formulations (Sulide, Nimside and others). Nimesulide is generally well tolerated, but side effects can include headache, dizziness, somnolence, gastrointestinal upset, nausea, abdominal discomfort, diarrhea, peripheral edema and hypersensitivity reactions. Rare but potentially serious adverse events from NSAIDs include gastrointestinal ulceration, bleeding, and perforation, an increased risk for serious cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, infertility, fetal toxicity, and acute hypersensitivity reactions including anaphylaxis, exfoliative dermatitis, and Stevens Johnson syndrome.

### Hepatotoxicity

Prospective studies show that up to 15% of patients taking NSAIDs experience at least transient serum aminotransferase elevations. A lower rate has been reported with nimesulide. These elevations are generally transient, mild and asymptomatic, and may resolve even with drug continuation. Marked aminotransferase elevations (>3 fold elevated) occur in <1% of patients. Nevertheless, nimesulide has been repeatedly linked to cases of clinically apparent liver injury with jaundice, with more than 100 cases described in the world's literature. The time to onset has ranged from a few days to 6 months, the usual latency being 4 weeks. The pattern of enzyme elevations is typically hepatocellular, although cholestatic forms have been described as well. Immunoallergic features are usually absent and, when present, are not prominent. Autoimmune features are rare. Most cases resolve beginning a few days after stopping therapy. However, multiple instances of acute liver failure with death or need for emergency liver transplantation have been described (Case 1). The mortality rate of nimesulide associated acute hepatitis with jaundice is between 10% and 20%. The overall frequency of nimesulide hepatotoxicity is not known, but it is usually mentioned in large case series on drug induced liver injury and acute liver failure, and a reasonable estimation is one in 50,000 users. Liver injury may be less common when the duration of therapy is limited to 15 days; however, severe cases of nimesulide liver injury have been reported after courses of therapy as short as 3 to 5 days.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of nimesulide hepatotoxicity is not known, but likely to be due to an idiosyncratic reaction to an intermediate of its metabolism. Nimesulide is extensively metabolized by the liver.

### Outcome and Management

Severity ranges from asymptomatic elevations in serum aminotransferase levels to symptomatic hepatitis with or without jaundice. Several cases of fulminant hepatitis attributed to nimesulide have been reported, and the overall mortality rate among jaundiced cases is between 10% and 20%. Recurrence upon rechallenge with nimesulide has been reported and should be avoided. There is no evidence for cross sensitivity to liver injury between nimesulide and other conventional NSAIDs, such as ibuprofen, naproxen or diclofenac. Because of the sulfonanilide structure of nimesulide, use of sulfonamides or other agents with a sulfonamide related structure (celecoxib, zonisamide) after clinically apparent liver injury from nimesulide should be done with caution.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORT

### Case 1. Acute liver failure attributed to nimesulide.(1)

A 58 year old woman began to feel unwell approximately 10 days after starting nimesulide for chronic back pain. She was seen and found to have mild elevations in serum enzymes (Table). Nimesulide was continued, but she developed further symptoms including nausea and it was stopped. Two weeks later, she noted dark urine and jaundice and shortly thereafter she was admitted to the hospital because of worsening symptoms. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. She had taken nimesulide for short periods in the past. Her other medications included birth control pills which she had taken for 6 years and sertraline which she had taken for 11 months. On admission, she was acutely ill with jaundice and confusion. Laboratory results showed a total bilirubin of 16.9 mg/dL, ALT 1046 U/L, AST 386 U/L, alkaline phosphatase 114 U/L, GGT 112 U/L, albumin 2.8 g/dL and INR greater than 12. Tests for hepatitis A, B, C, EBV and CMV were negative. She had low titers of ANA (1:25). Abdominal ultrasound showed normal liver, spleen and biliary system and a small amount of ascites. She rapidly deteriorated and required assisted ventilation. She developed progressive hepatic failure and underwent emergency liver transplantation within 3 days of admission, but had primary graft nonfunction, multiorgan failure and died within a day of the surgery. Autopsy revealed massive hepatic necrosis.

#### Key Points

Medication: | Nimesulide (100 mg twice daily)
Pattern: | Hepatocellular (R=~62)
Severity: | 5+ (jaundice, hepatic failure, liver transplantation, death)
Latency: | 10 days to symptoms, 50 days to jaundice
Recovery: | None
Other medications: | Oral contraceptives, sertraline

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 0 | 23 | 51 | | Routine
10 days | 0 | 187 | 50 | | Nonspecific symptoms
32 days | 0 | 504 | 54 | 0.9 | Nausea
50 days | 2 weeks | 2857 | 114 | 7.0 | Admission, confusion
53 days | | Liver transplantation, primary nonfunction, death
Normal Values | | <40 | <100 | <1.2

#### Comment

This was one of the earliest reported cases of acute liver failure attributed to nimesulide. The latency to onset was actually quite short, within 2 weeks of starting. Symptoms were vague and not specific. Her liver tests were abnormal, but nimesulide was continued. She continued to feel worse and eventually developed jaundice followed by hepatic failure. She was acutely ill on hospital admission and was rapidly listed for emergency liver transplantation, which was carried out on day 3. She suffered primary graft nonfunction, however, and died of multiorgan failure. The majority of cases of acute liver failure due to nimesulide have been in middle aged women with onset within 2 weeks to 3 months of starting. The shorter latencies may correlate with previous exposure.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nimesulide – Generic, Sulide®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nimesulide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nimesulide | 51803-78-2 | C13-H12-N2-O5-S

## CITED REFERENCE

1 McCormick PA, Kennedy F, Curry M, et al. COX-2 inhibition and fulminant hepatic failure Lancet 1999; 353 (9146): 40-1. .10023957

## ANNOTATED BIBLIOGRAPHY

References updated: 10 August 2025

Abbreviations used: NSAID, nonsteroidal anti-inflammatory drug; COX-1 and -2, cyclo-oxygenase 1 and 2; DRESS, drug reaction with eosinophilia and systemic symptoms.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999; nimesulide is described as a newly introduced NSAID that had led to at least 6 reported cases of hepatic injury reported, all from one institution [Van Steenberger 1998]).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd. Amsterdam: Elsevier, 2013, pp. 369-401. (Review of hepatotoxicity of NSAIDs mentions that many cases of hepatotoxicity from nimesulide have been reported).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Kromann-Andersen H, Pedersen A. Reported adverse reactions to and consumption of nonsteroidal anti-inflammatory drugs in Denmark over a 17-year period. Dan Med Bull 1988; 35: 187-92. (Over a 17 year period, 3521 suspected adverse drug reactions due to NSAIDs were reported to a Danish National Registry, of which 3% were liver related, 3% of which [n=3] were fatal, 2 due to benoxaprofen and one to indomethacin; nimesulide was not widely available at this time). 2966038
Hannequin JR, Doffoel M, Schmutz G. [Hepatitis secondary to current non-steroidal anti-inflammatory agents]. Rev Rhum Mal Osteoartic 1988; 55: 983-8. French. PMID: 3070713 (Review of published literature on hepatotoxicity of NSAIDs mentions 28 cases attributed to ibuprofen, 21 sulindac, 6 piroxicam, 5 diclofenac, 5 indomethacin, 4 naproxen and 1 fenoprofen; nimesulide was not yet available in France).
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-8. (Extensive review of NSAID related liver injury before the wide scale availability of nimesulide). 2281340
Walker AM. Quantitative studies of the risk of serious hepatic injury in persons using nonsteroidal antiinflammatory drugs. Arthritis Rheum 1997; 40: 201-8. (Review of population based studies of NSAID use and hepatic injury; frequency of clinically apparent liver injury from NSAIDs overall was ~10 cases per 100,000 patient-years of use; studies were conducted before the availability of nimesulide). 9041931
Bessone F, Fay F, Fay O, Vorobioff J, Passamonti ME, Godoy A, Tanno H. Nimesulide hepatotoxicity. Hepatology 1997; 26 (Suppl 4): 483A. Not in PubMed (Abstract: 12 patients with suspected nimesulide hepatotoxicity were seen over a 10 year period; 8 with jaundice, 9 pruritus, mean latency 25 days [mean bilirubin 3.4 mg/dL, ALT 276 U/L, Alk P 115 U/L], all recovered an average of 55 days after stopping).
Rainsford KD. An analysis from clinico-epidemiological data of the principal adverse events from the COX-2 selective NSAID, nimesulide, with particular reference to hepatic injury. Inflammopharmacology 1998; 6: 203-21. (Retrospective summary of adverse events from clinical trials of nimesulide found ALT or AST elevations in 1-10% of patients, but degree of monitoring not described; there were 25 cases of hepatic injury reported worldwide after sales of at least 130 million doses, some cases resulting in hospitalization and some in death, but in many "the association could be questioned"). 17657620
Van Steenbergen W, Peeters P, De Bondt J, Staessen D, Büscher H, Laporta T, Roskams T, Desmet V. Nimesulide-induced acute hepatitis: evidence from six cases. J Hepatol 1998; 29: 135-41. (Description of 6 cases of suspected nimesulide liver injury seen over a 9 month period at a single referral center in Belgium included 4 women and 2 men, ages 39 to 71 years, taking drug for 1-15 weeks [bilirubin 2-30 mg/dL, ALT 3-23 times ULN, Alk P 1.4-2.8 times ULN], two cholestatic and 4 hepatocellular, one severe, all resolving slowly within 6-17 months of stopping). 9696502
Grignola JC, Arias L, Rondan M, Sola L, Bagnulo H. [Hepatotoxicity associated with nimesulide]. Arch Med Int 1998; Unknown: 13-18. Not in PubMed (Case report mentioned in Hernández [1014]).
McCormick PA, Kennedy F, Curry M, Traynor Ol. COX-2 inhibition and fulminant hepatic failure Lancet 1999; 353 (9146): 40-1. (58 year old woman developed jaundice after several months of intermittent courses of nimesulide [bilirubin 16.9 mg/dL, ALT 1046 U/L, Alk P not given, INR 12], with progressive hepatic failure and death shortly after liver transplantation: Case 1). 10023957
Villa G. NSAIDs and hepatic reactions. Lancet 1999; 353: 846. (Letter in response to McCormick [1999] arguing caution in attributing the liver injury to nimesulide). 10459994
Weiss P, Mouallem M, Bruck R, Hassin D, Tanay A, Brickman CM, Farfel Z, et al. Nimesulide-induced hepatitis and acute liver failure. Isr Med Assoc J 1999; 1: 89-91. (Six cases of suspected nimesulide hepatotoxicity; 5 women and 1 man, ages 18 to 70 years, with onset after 2 weeks to 4 months, 5 being anicteric [3 hepatocellular, 2 cholestatic enzyme elevations], these 5 resolving in 1-3 months of stopping, but one case of jaundice, acute liver failure and death). 10731303
Romero Gómez M, Nevado Santos M, Fobelo MJ, Castro Fernández M. [Nimesulide acute hepatitis: description of 3 cases]. Med Clin(Barc) 1999; 113(9): 357-8. Spanish. PMID: 10562933 (3 cases of acute hepatitis attributed to nimesulide seen at a single center, all women, ages 61-65 years, onset after 1-2 months with jaundice and hepatocellular enzyme elevations [bilirubin 7.8, 13.6 and 24 mg/dL, ALT 483, 1234 and 4023 U/L, Alk P 310, 456 and 675 U/L], resolving within 1-4 months of stopping).
Schattner A, Sokolovskaya N, Cohen J. Fatal hepatitis and renal failure during treatment with nimesulide. J Intern Med 2000; 247: 153-5. (70 year old woman developed jaundice a few days after a 5 day course of nimesulide [bilirubin 12.6 mg/dL, ALT 1240 U/L, Alk P 285 U/L, INR 2.3], with progressive hepatic failure and death 3 weeks later). 10672143
Elmalem E. Nimesulide, clavulanic acid and hepatitis. J Intern Med 2000; 248: 168-9. (Letter in response to Schattner [2000] from the sponsor raising issue of the possible role of amoxicillin/clavulanate and mentioning the new recommendation for liver enzyme monitoring during therapy with nimesulide). 10947899
Ferreiro C, Vivas S, Jorquera F, Domínguez AB, Espinel J, Muñoz F, Herrera A, et al. [Toxic hepatitis caused by nimesulide, presentation of a new case and review of the literature]. Gastroenterol Hepatol 2000; 23: 428-30. Spanish. PMID: 11126038 (72 year old woman developed jaundice 15 days after starting nimesulide [bilirubin 7.8 mg/dL, ALT 696 U/L, Alk P 452 U/L, eosinophils 5%], resolving within 3 months of stopping).
Andrade RJ, Lucena MI, Fernández MC, González M. Fatal hepatitis associated with nimesulide. J Hepatol 2000; 32: 174. (66 year old woman developed jaundice 8 months after starting nimesulide [bilirubin 18.4 mg/dL, ALT 885 U/L, Alk P not given, prothrombin index 35%], with progressive liver failure and death 8 days later). 10673086
Rodrigues de Oliveira J, Correia J, Silvestre F, Meirelles A, Bernardo A. [Severe acute hepatitis probably induced by nimesulide]. Gastroenterol Clin Biol 2000; 24: 592-3. French. PMID: 10891757 (47 year old man on nimesulide for several years developed nausea one month after restarting nimesulide after hernia surgery [and cefazolin] followed by jaundice 2 months later [bilirubin 7.9 mg/dL, ALT 93 times ULN, Alk P 1.5 times ULN, prothrombin time 42 sec], with subsequent ascites and peak bilirubin of 17.8 mg/dL, ultimately resolving).
Pérez-Moreno J, Llerena Guerrero RM, Puertas Montenegro M, Jiménez Arjona MJ. [Nimesulide toxic hepatitis in pregnancy]. Gastroenterol Hepatol 2000; 23: 498-9. Spanish. PMID: 11149228 (22 year old woman, 5 weeks pregnant, developed jaundice 5 days after starting nimesulide for a sprained ankle [bilirubin 4.7 mg/dL, ALT 635 U/L, Alk P 309 U/L], resolving within a month of stopping).
Bessone F, Tanno H. [Hepatotoxicity induced by non-steroidal anti-inflammatory drugs]. Gastroenterol Hepatol 2000; 23: 200-5. (Review of drug induced liver injury due to NSAIDs mentions that nimesulide was approved in Argentina in 1986 and during the ensuing 10 years, they observed 12 patients with acute liver injury, usually cholestatic and self-limited, but also with hepatocellular injury that can be severe and even fatal). 10863862
Sbeit W, Krivoy N, Shiller M, Farah R, Cohen HI, Struminger L, Reshef R. Nimesulide-induced acute hepatitis. Ann Pharmacother 2001; 35: 1049-52. (54 year old woman developed fever and jaundice two months after starting nimesulide for low back pain [bilirubin 12.9 mg/dL, ALT 2842 U/L, Alk P 748 U/L, INR 1.59, eosinophils 9%], with resolution within 2 months of stopping). 11573855
Montesinos S, Hallal H, Rausell V, Conesa F, López A. [Nimesulide-induced acute hepatitis]. Gastroenterol Hepatol 2001; 24: 219-20. Spanish. PMID: 11333664 (64 year old man developed jaundice 6 months after starting nimesulide [bilirubin 17.6 mg/dL, ALT 1705 U/L, Alk P 512 U/L], resolving once the drug was stopped).
Knowles S, Shapiro L, Shear NH. Should celecoxib be contraindicated in patients who are allergic to sulfonamides? Revisiting the meaning of 'sulfa' allergy. Drug Saf 2001; 24: 239-47. (Analysis of data on hypersensitivity reactions to sulfonamides and subsequent risk of hypersensitivity reactions to celecoxib and other sulfonamide-like drugs found little evidence for cross sensitivity). 11330653
Conforti A, Leone R, Moretti U, Mozzo F, Velo G. Adverse drug reactions related to the use of NSAIDs with a focus on nimesulide: results of spontaneous reporting from a Northern Italian area. Drug Saf 2001; 24: 1081-90. (Analysis of spontaneous adverse event reports attributed to nimesulide over a 13 year period in Northern Italy found 207 reports mostly of gastrointestinal complaints, with only 4 reports of hepatitis and 3 of Stevens Johnson syndrome). 11735663
Merlani G, Fox M, Oehen HP, Cathomas G, Renner EL, Fattinger K, Schneemann M, et al. Fatal hepatoxicity secondary to nimesulide. Eur J Clin Pharmacol 2001; 57: 321-6. (57 year old woman developed jaundice 3 months after starting nimesulide [bilirubin 28.6 mg/dL, ALT 2786 U/L, Alk P 225 U/L, prothrombin index 32%], with progressive liver failure, oliguria and death 3 weeks after presentation). 11549211
Dumortier J, Borel I, Delafosse B, Vial T, Scoazec JY, Boillot O. [Subfulminant hepatitis associated with nimesulide treatment requiring liver transplantation]. Gastroenterol Clin Biol 2002; 26: 415-6. French. PMID: 12070417 (51 year old man developed fatigue 14 days after a 7 day course of nimesulide followed by jaundice [bilirubin 17.7 mg/dL, ALT 50 times ULN, Alk P 10 times ULN, prothrombin index 24%], with subsequent liver failure and successful liver transplantation 14 days later).
Gatti S, Bertazzoli M. Evaluation of isolated case reports on hepatotoxicity. Eur J Clin Pharmacol 2002; 57: 919-20; author reply 921-2. (Letter in response to Merlani [2001] questioning the validity of reporting isolated cases of liver injury during drug therapy as opposed to providing an absolute risk assessment in prospective studies). 11936716
Rodrigo L, de Francisco R, Pérez-Pariente JM, Cadahia V, Tojo R, Rodriguez M, Lucena MI, Andrade RJ. Nimesulide-induced severe hemolytic anemia and acute liver failure leading to liver transplantation. Scand J Gastroenterol 2002; 37: 1341-3. (63 year old woman developed jaundice 7 months after starting nimesulide for osteoarthritis [bilirubin 33.9 mg/dL, ALT 143 U/L, Alk P 1099 U/L], which was complicated by severe hemolytic anemia with hepatic failure and death 23 days after admission). 12465736
Gallego Rojo FJ, Fernández Pérez F, Fernández Pérez R, Porcel A, Blas JM, Díez F. [Nimesulide-induced hepatotoxicity]. Rev Esp Enferm Dig 2002; 94: 41-2. Spanish. PMID: 12073669 (83 year old man developed jaundice 2 weeks after starting nimesulide [bilirubin 6.3 mg/dL, ALT 811 U/L, Alk P 780 U/L], resolving within 2 months of stopping).
Stadlmann S, Zoller H, Vogel W, Offner FA. COX-2 inhibitor (nimesulide) induced acute liver failure. Virchows Arch 2002; 440: 553-5. (36 year old woman developed abdominal pain and confusion one month after starting nimesulide [bilirubin 2.2 mg/dL, ALT 1115 U/L, Alk P not given, prothrombin index 39%], biopsy showing centrolobular, confluent necrosis, yet with resolution within 3 weeks of stopping). 12021934
Boelsterli UA. Mechanisms of NSAID-induced hepatotoxicity: focus on nimesulide. Drug Saf 2002; 25: 633-48. (Review of the possible mechanisms of hepatic injury caused by NSAIDs with focus on nimesulide, described as a rare cause of hepatotoxicity). 12137558
Maciá MA, Carvajal A, del Pozo JG, Vera E, del Pino A. Hepatotoxicity associated with nimesulide: data from the Spanish Pharmacovigilance System. Clin Pharmacol Ther 2002; 72: 596-7. (Analysis of Spanish Pharmacovigilance Database found that among NSAIDs, nimesulide was associated with the highest rate of liver injury [29 cases, ~1:15,000 persons exposed], the second being meloxicam [16 cases: ~1:70,000]). 12426524
Traversa G, Bianchi C, Da Cas R, Abraha I, Menniti-Ippolito F, Venegoni M. Cohort study of hepatotoxicity associated with nimesulide and other non-steroidal anti-inflammatory drugs. BMJ 2003; 327(7405): 18-22. (Retrospective study of all patients prescribed nimesulide in a region of Northern Italy between 1997 and 2001 identified 17 cases of acute liver injury with hospitalization [one fatal] among 187,312 users, yielding an overall rate of 1.3 per 100,000 person-years, minimally greater than with other NSAIDs). 12842950
Papaioannides D, Korantzopoulos P, Athanassiou E, Sinapidis D. Nimesulide-induced acute hepatotoxicity. Indian J Gastroenterol 2003; 22: 239. (62 year old man developed jaundice 1 week after starting nimesulide for gonarthritic pain. [bilirubin 4.2 mg/dL, ALT 1270 U/L, Alk P 185 U/L, INR normal], resolving within 4 weeks of stopping). 15030049
Ozgür O, Hacihasanoglu A, Karti SS, Ovali E. Nimesulide-induced fulminant hepatitis. Turk J Gastroenterol 2003; 14: 208-10. (18 year old boy developed jaundice 3 days after starting nimesulide for a muscle strain [bilirubin 3.6 mg/dL, ALT 1528 U/L, Alk P 510 U/L, INR 1.9], with confusion and ascites, but eventual resolution within 1 month of stopping). 14655069
Castañeda Hernández G, Barragán Padilla SB. [Hepatotoxicity of nimesulide]. Gac Med Mex 2004; 140: 679. Spanish. PMID: 15633581 (Letter to the editor cautioning against use of nimesulide in Mexico in view of it having been withdrawn in Finland, Spain and Portugal because of hepatotoxicity).
Lacroix I, Lapeyre-Mestre M, Bagheri H, Pathak A, Montastruc JL; Club de Reflexion des cabinets de Groupe de Gastro-Enterologie (CREGG); General Practitioner Networks. Nonsteroidal anti-inflammatory drug-induced liver injury: a case-control study in primary care. Fundam Clin Pharmacol 2004; 18: 201-6. (Case controlled study of patients presenting with suspected drug induced liver injury in a general practice context in Southern France between 1998 and 2001 found 88 cases which were matched with 178 controls; 22 cases vs 16 controls had been exposed to NSAIDs; 5 diclofenac, 4 ibuprofen, 4 ketoprofen, 2 niflumic acid, 1 flurbiprofen and 1 meloxicam, the rest to salicylates which were as frequently used in controls as cases; there were no fatalities and cases were more common in women than men, no mention of nimesulide). 15066135
Rubenstein JH, Laine L. Systematic review: the hepatotoxicity of non-steroidal anti-inflammatory drugs. Aliment Pharmacol Ther 2004; 20: 373-80. (NSAIDs are the most commonly used drugs in the US and account for a large proportion of cases of hepatic injury, but the frequency is quite rare. Among 7 population based studies, hospitalization occurred in 22.4/100,000 patient-years of NSAID use [33.1/100,000 for nimesulide] and deaths from liver injury occurred in ~1/100,000 patient-years; in case controlled studies, higher odds ratio for liver injury was found with sulindac and nimesulide). 15298630
Gallelli L, Ferraro M, Mauro GF, De Fazio S, De Sarro G. Nimesulide-induced hepatotoxicity in a previously healthy woman. Clin Drug Investig 2005; 25: 421-4. (70 year old woman developed nausea and fatigue within 8 hours of taking a single tablet of nimesulide [bilirubin 0.9 mg/dL, ALT 224 U/L, Alk P 65 U/L, INR 2.3], values falling into the normal range within 7 days). 17532683
Giannattasio A, D'Ambrosi M, Volpicelli M, Iorio R. Steroid therapy for a case of severe drug-induced cholestasis. Ann Pharmacother 2006; 40: 1196-9. (15 year old girl developed jaundice 15 days after starting clarithromycin and nimesulide for a respiratory tract infection [bilirubin 10.6 rising to 25.6 mg/dL, ALT 69 U/L, GGT normal], with severe itching treated with ursodiol and corticosteroids, resolving slowly by 3 months after stopping both drugs). 16720710
Polimeni G, Salvo F, Cutroneo P, Morreale I, Patrizio Caputi A. Adverse reactions induced by NSAIDs and antibacterials: analysis of spontaneous reports from the Sicilian regional database. Drug Saf 2006; 29 (5): 449-59. (Analysis of spontaneous adverse reactions reported to Sicilian registries between 1998 and 2004 found 108 serious reactions to NSAIDs, with disproportional reports of hepatitis from nimesulide [3 cases resulting in liver transplantation]). 16689558
Lapeyre-Mestre M, de Castro AM, Bareille MP, Garcia del Pozo J, Requejo AA, Arias LM, Montastruc J-L, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20: 391-5. (Analysis of adverse event reports from NSAIDs from France and Spain from 1982-2001; the proportion of reports that were hepatic was high for nimesulide in Spain [17.3%] and France [16.1%], but the odds ratio was elevated for hepatic injuries and nimesulide only in Spain [6.04]). 16867024
Arellano FM, Yood MU, Wentworth CE, Oliveria SA, Rivero E, Verman A, Rothman K. Use of cyclo-oxygenase 2 inhibitors (COX-2) and prescription non-steroidal anti-inflammatory drugs (NSAIDS) in UK and USA populations Implications for COX-2 cardiovascular profile. Pharmacoepidemiol Drug Saf 2006; 15: 861-72. (Surveys from the UK and USA indicate that ibuprofen, naproxen and diclofenac were the most commonly used NSAIDs; nimesulide was not among the top 10 agents used). 17086563
Sanchez-Matienzo D, Arana A, Castellsague J, Perez-Gutthann S. Hepatic disorders in patients treated with COX-2 selective inhibitors or nonselective NSAIDs: a case/noncase analysis of spontaneous reports. Clin Ther 2006; 28: 1123-32. (Analysis of large databases from the FDA and WHO on spontaneous reports of adverse reactions to NSAIDs found the highest proportion of hepatic injury reports for nimesulide, bromfenac, diclofenac and sulindac compared to other NSAIDs). 16982289
Aithal GP, Day CP. Nonsteroidal anti-inflammatory drug-induced hepatotoxicity. Clin Liver Dis 2007; 11: 563-75, vi-vii. PMID: 17723920 (Review of NSAID induced liver injury mentions that nimesulide was never marketed in the US, but was available in over 50 countries and the most commonly prescribed NSAID in Italy and Portugal despite its withdrawal in Finland and Spain because of hepatotoxicity).
Tan HH, Ong WM, Lai SH, Chow WC. Nimesulide-induced hepatotoxicity and fatal hepatic failure. Singapore Med J 2007; 48: 582-5. (Three Chinese adults, two women and one man, ages 54-71 years, developed jaundice 19-28 days after starting nimesulide [bilirubin 3.6, 3.1 and 45.3 mg/dL, ALT 23-31 times ULN], two resolving after stopping and one developed fatal acute liver failure, an autopsy revealing cirrhosis). 17538762
Dastis SN, Rahier J, Lerut J, Geubel AP. Liver transplantation for nonsteroidal anti-inflammatory drug-induced liver failure: nimesulide as the first implicated compound. Eur J Gastroenterol Hepatol 2007; 19: 919-22. (Among 57 patients undergoing liver transplantation for acute liver failure during a 17 year period at a single referral center in Belgium, 5 were attributed to NSAIDs including 3 to nimesulide; 22-59 year old women exposed for 2 days to 2 months [bilirubin 10-22 mg/dL, ALT 21-34 times ULN], successfully transplanted within 1-7 days of presentation with encephalopathy). 18049158
Bissoli F. Negrin Dastis S. et al.: Liver transplantation for nonsteroidal anti-inflammatory drug-induced liver failure: nimesulide as the first implicated compound. Eur J Gastroenterol Hepatol 2008; 20: 1122. (Letter in response to Dastis [2007] arguing that case reports of drug induced acute liver failure provide a safety signal, but only prospective studies can provide information of the frequency of liver injury and establish causality). 19047848
Bissoli F. Nimesulide-induced hepatotoxicity and fatal hepatic failure. Singapore Med J 2008; 49: 436-7; author reply 438. (Letter in response to Tan [2007] stressing that acute liver failure from nimesulide is very rare). 18465058
Chatterjee S, Pal J, Biswas N. Nimesulide-induced hepatitis and toxic epidermal necrolysis. J Postgrad Med 2008; 54: 150-1. (21 year old woman developed extensive exfoliative rash 5 days after starting nimesulide followed by fever and jaundice [bilirubin 3.4 mg/dL, ALT 340 U/L, Alk P 696 U/L], with prolonged hospital stay and corticosteroid therapy, but ultimate full recovery). 18480536
Page M, Christin F, Hayi-Slayman D, Baillon JJ, Ber CE, Delafosse B, Dumortier J, Rimmelé. [Acute liver failure due to a treatment by nimesulide: another case and review]. Ann Fr Anesth Reanim 2008; 27: 742-6. French. PMID: 18760563 (49 year old woman developed acute liver failure one month after a 3 day course of nimesulide [bilirubin and Alk P not given, ALT 1435 U/L, prothrombin index 24%], undergoing successful emergency liver transplantation).
Koller T, Banárová A, Ondrias F, Kollerová J, Payer J. [Acute cholestasis following treatment with nimesulide and oral contraception: case report and review]. Vnitr Lek 2008; 54: 665-9. Slovak. PMID: 18672579 (42 year old woman developed jaundice one month after a 10 day course of nimesulide having been on birth control pills for 8 years [bilirubin 11 mg/dL, ALT 175 U/L, Alk P 180 U/L], with bland cholestasis on liver biopsy and recovery within two months).
Walker SL, Kennedy F, Niamh N, McCormick PA. Nimesulide associated fulminant hepatic failure. Pharmacoepidemiol Drug Saf 2008; 17: 1108-12. (Retrospective analysis of all cases of acute liver failure of unknown cause undergoing liver transplantation at a single center in Ireland between 1994 and 2007 found 6 probably due to nimesulide: 5 women and 1 man, ages 23-61 years, on drug for 1 week to 2 months of whom 2 died and 4 underwent successful liver transplant). 18821716
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network(DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; none were attributed to fenoprofen). 18955056
Leone R, Sottosanti L, Luisa Iorio M, Santuccio C, Conforti A, Sabatini V, Moretti U, et al. Drug-related deaths: an analysis of the Italian spontaneous reporting database. Drug Saf 2008; 31: 703-13. (Analysis of fatal adverse drug reactions reported to an Italian registry between 2001 and 2006, identified 450 case reports implicated 222 different drugs, the most common being antiinfectives and antineoplastic agents, specific agents being ceftriaxone [n=24], triclopidine [22], nimesulide [17], amiodarone [13], allopurinol [12], simvastatin [12] and acetaminophen [10]). 18636789
Betrosian AP, Flevari K, Andrianakis I, Boudouri I, Douzinas EE. Severe hemolytic anemia and fatal hepatic failure associated with nimesulide. Dig Liver Dis 2009; 41: 80. (61 year old woman developed jaundice 3 months after starting nimesulide which was used intermittently [bilirubin 11.2 mg/dL, ALT 762 U/L, INR 3.9, hemoglobin 6 g/dL, LDH 8867 U/L, direct Coombs positivity], dying of liver failure within 4 days of presentation). 18778975
Wang YP, Shi B, Chen YX, Xu J, Jiang CF, Xie WF. Drug-induced liver disease: an 8-year study of patients from one gastroenterological department. J Dig Dis 2009; 10: 195-200. (Retrospective analysis of 30 cases of drug induced liver injury seen in a single referral center in Shanghai between 2000-2007 found one case due to nimesulide: 58 year old woman treated for 2 weeks developed hepatocellular liver injury [bilirubin 1.5 mg/dL, ALT 20 times ULN, Alk P 1.1 times ULN], resolving promptly with stopping nimesulide). 19659787
Altwegg R. [Acute liver failure due to a treatment by nimesulide]. Ann Fr Anesth Reanim 2009; 28: 262-3. French. PMID: 19195818 (Letter in response to Page [2008) questioning the attribution of the injury to nimesulide, which had been stopped two months before onset).
Lukic S. S, Krstic M, Damjanov N, Boricic I, Popovic D, Djuranovic S, Kovacevic N, et al. [Cholestatic hepatitis associated with nimesulide--a case report]. Srp Arh Celok Lek 2009 Sep-Oct; 137 (9-10): 550-3. Serbian. PMID: 19950766 (Abstract: 73 year old woman developed acute liver failure 2 months after starting nimesulide, recovering upon stopping).
Licata A, Calvaruso V, Cappello M, Craxì, Almasio PL. Clinical course and outcomes of drug-induced liver injury: nimesulide as the first implicated medication. Dig Liver Dis 2010; 42: 143-8. (Among 46 patients with drug induced liver injury seen at a single referral center in Italy over a 10 year period, 14 [30%] were attributed to nimesulide, 7 men and 7 women, mean age 58 years, 11 with jaundice including 3 cases of acute liver failure and 1 death, others recovering in an average of 4 weeks with normal liver tests in follow up). 19625223
Lee CH, Wang JD, Chen PC. Increased risk of hospitalization for acute hepatitis in patients with previous exposure to NSAIDs. Pharmacoepidemiol Drug Saf 2010; 19: 708-14. (Analysis of hospitalizations for acute, non-viral hepatitis in Taiwan been 2001 and 2004 found 4519 cases with an increased odds ratio for use of NSAIDs within the previous month, highest for nimesulide, ibuprofen and diclofenac). 20582911
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; largest series on nimesulide was from Argentina with 43 cases, 70% with jaundice, usually arising 15-90 days after starting, 6 with acute liver failure and 2 deaths). 21128314
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 7 to NSAIDs, including 4 to bromfenac, 2 diclofenac and 1 etodolac, but none to nimesulide which was never marketed in the US). 20949552
Bessone F, Colombato L, Fassio E, Reggiardo M, Vorobioff J, Tanno H. The spectrum of nimesulide induced hepatotoxicity. An overview. Antiinflamm Antiallergy Agents Med Chem 2010; 9: 355-65. Not in PubMed (Mentioned in Hernández [2014]).
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. (Among 600 patients undergoing liver transplantation for acute liver failure at 52 European liver transplant centers between 2005 and 2007, 301 were considered idiopathic and had received a medication within 30 days of onset, including acetaminophen in 192 and NSAIDs in 40 cases of which nimesulide was used in 8 for an estimated rate of 1.88 case per million treatment-years). 23325533
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Association Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of serious adverse events reporting to a French pharmacovigilance database found highest cumulative rates for liver related reports for nimesulide [0.15 per million defined daily doses], followed by diclofenac [0.09], ketoprofen [0.09], piroxicam [0.06], naproxen [0.04] and meloxicam [0.03] being significant in case/noncase analyses for nimesulide, diclofenac and piroxicam only). 21929527
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to nimesulide, probably because it is not marketed in Iceland). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 published reports of drug induced liver injury between 1996 and 2012, nimesulide was the single most common cause a counting for 53 cases [30%], of which 13 [25%] resulted in acute liver failure). 24552865
Bernardes SS, Souza-Nogueira A, Moreira EG, Kishima MO, Guembarovski AF, Turini TL, Turini CA. Nimesulide-induced fatal acute liver failure in an elderly woman with metastatic biliary adenocarcinoma. A case report. Sao Paulo Med J 2014 Sep 19. [Epub ahead of print] (81 year old woman developed hematemesis 6 days after starting nimesulide and was found to have hypotension, metabolic acidosis and respiratory failure [bilirubin 4.0 mg/dL, ALT 60 U/L, Alk P 260 U/L], with rapid progression to multiorgan failure and death, metastatic bile duct adenocarcinoma and acute hepatic necrosis found on autopsy). 25250798
Bhattacharya PK, Barman B, Roy A, Jamil M, Lyngdoh M, Mishra J. Nimesulide induced leukocytoclastic vasculitis and hepatitis: a case report. Springerplus 2015; 4: 302. (38 year old woman developed rash, pruritus and liver injury 4 days after starting nimesulide for fever [bilirubin 6.0 mg/dL, ALT 173 U/L, Alk P 467 U/L, INR 1.47], skin biopsy showing leukocytoclastic vasculitis, resolving with corticosteroid therapy within 3 weeks of stopping nimesulide). 26155441
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 cases were attributed to NSAIDs including 15 to diclofenac, 3 celecoxib, 3 meloxicam, 2 oxaprozin, 2 etodolac, and 1 each for ibuprofen, sulindac and valdecoxib, but none for nimesulide which was not marketed in the US). 25754159
Magalhães R, Fonseca M, Brandão I, Caridade S. Autoimmune hepatitis unmasked by nimesulide. BMJ Case Rep. 2016;2016:bcr2015212884.. (49 year old woman developed dark urine and jaundice 1-2 weeks after a 3 day course of nimesulide for oral pain [bilirubin 13.0 mg/dL, ALT 2558 U/L, Alk P 174 U/L, INR 2.2, IgG 2970 mg/dL, ANA 1:80, SMA 1:80] biopsy showing severe hepatitis and micronodular cirrhosis and subsequently she responded to immunosuppressive therapy , repeat biopsy showing only mild fibrosis). 26791119
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al.; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol. 2016;82:238-48.. (Among 179 cases of acute liver injury and 1770 case controls admitted to 9 Italian hospitals between 2010 and 2014, NSAIDs used more frequently in cases compared to controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59], and risk was higher in those taking higher doses). 26991794
Sriuttha P, Sirichanchuen B, Permsuwan U. Hepatotoxicity of nonsteroidal anti-inflammatory drugs: a systematic review of randomized controlled trials. Int J Hepatol. 2018;2018:5253623.. (Systematic review of randomized controlled trials of NSAIDs that reported monitoring for hepatoxicity identified 18 studies but only 3 NSAIDs showed an increase rates of liver injury with the drug compared to placebo, including diclofenac, celecoxib, and etoricoxib). 29568654
Pinto D, Silva A, Heleno B, Rodrigues DS, Santos I, Caetano PA. Effect of European Medicines Agency's regulatory measures on nimesulide utilization in Portugal. Pharmacoepidemiol Drug Saf. 2018;27:630-637.. (Between 2006 and 2015, dispensing rates for nimesulide in Portugal decreased markedly while rates for dispensing etoricoxib, ibuprofen and naproxen increased but the number of reports of nimesulide severe hepatic events did not change perhaps because of heightened awareness). 29602246
Kwon J, Kim S, Yoo H, Lee E. Nimesulide-induced hepatotoxicity: a systematic review and meta-analysis. PLoS One. 2019;14e0209264. PMID: 30677025. (A systematic review identified 25 observational studies [mainly from Europe] demonstrating an increased risk of hepatotoxicity with use of nimesulide and that the rate of death or liver transplantation in case reports and series was 46% ).
Prado NMBL, Messias GC, Santos Junior GO, Nunes VS, Schinonni MI, Paraná R. Prospective monitoring of drug use: drug-induced liver injury in a primary healthcare center. Arq Gastroenterol. 2019;56:390-393.. (Among 149 outpatients started on a new medication who returned for re-evaluation 30 days later, 3 had developed elevations of ALT, AST, and GGT, who were on nimesulide, budesonide and valacyclovir, all were asymptomatic and anicteric, and the abnormalities resolved within 2 months of stopping the medication). 31721973
Low EXS, Zheng Q, Chan E, Lim SG. Drug induced liver injury: East versus West - a systematic review and meta-analysis. Clin Mol Hepatol. 2020;26:142-154.. (Literature searches on the frequency of drug-induced liver injury identified 12 reports from the East [33,294 patients] and 16 in the West [26,069]; major differences were found in the most frequently implicated drugs: antituberculosis agents, phenytoin, and cephalosporins in the East and amoxicillin/clavulanate [11.3%], nimesulide [6.3%] and ibuprofen [6.1%] in the West). 31816676
Bessone F, Hernandez N, Mendizabal M, Ridruejo E, Gualano G, Fassio E, Peralta M, et al. Serious liver injury induced by nimesulide: an international collaborative study. Arch Toxicol. 2021;95:1475-1487.. (Among 57 cases of nimesulide induced liver injury enrolled in the Spanish and Latin American Registries between 1988 and 2009, mean age was 59 years, median time to onset 40 days, 89% were women, 81% with jaundice, 67% hepatocellular enzyme pattern; mean ALT 20 times, Alk P 2 times, and bilirubin 13 times ULN; 21% developed acute liver failure, 5 died and 3 underwent liver transplantation). 33759010
Umar M, Bin Naeem MA. Rampant use of nimesulide in Pakistan, a drug associated with hepatotoxicity. J Pak Med Assoc. 2023;73:1771.. (Letter mentioning that nimesulide is over-the-counter and frequently used in Pakistan). 37697794
Patil S, Nadaf N, Gupta S, Barai P, Makhija S, Lodha P, Patel C, et al. A comparative analysis of the efficacy and safety of nimesulide/paracetamol fixed-dose combination with other NSAIDs in acute pain management: a randomized, prospective, multicenter, active-controlled study (the SAFE-2 Study). Cureus. 2024;16:e58859.. (Among 600 adults with acute painful conditions treated with one of 4 analgesic preparations for 7 days, pain reduction was greatest with the nimesulide-acetaminophen fixed dose combination and both total adverse event rates [9.3% vs 14.0% to 21.3%] and liver enzyme elevations [2.0% vs 2.6% to 4.0%] were lower with the nimesulide product compared to others). 38800230
Wang L, Ma R, Du W. A report on the use and safety of nonsteroidal anti-inflammatory drugs among 22,553 children from sample hospitals in Shanghai. Altern Ther Health Med. 2024;30:374-377.. (Among 22,553 children [ages 0 to 12 years] treated with NSAIDs during a stay in 14 hospitals in Shanghai between 2005 and 2011, 4745 received nimesulide, 6265 acetaminophen, and 11,543 ibuprofen and rates of “abnormal liver function” was lowest with nimesulide [18.3% vs 24.2% and 27.3%]). 38466056

## OTHER REFERENCE LINKS

1. Recent References on Nimesulide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nimesulide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Nimesulide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nimesulide)